# Oxycodone

## OVERVIEW

### Introduction

Oxycodone is a semisynthetic, moderately potent, orally available opioid that is widely used for acute or chronic management of moderate- or moderately severe pain either alone or in combination with acetaminophen. Oxycodone by itself has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury. However, the combination of oxycodone with acetaminophen has been linked to many cases of acute liver failure caused by unintentional overdose with acetaminophen.

### Background

Oxycodone (ox” i koe’ done) is a semisynthetic derivative of thebaine, a natural alkaloid found in the resin of poppy seeds (Papaver somniferum). It is well absorbed orally and has moderate opiate activity, acting as an agonist of the u type opiate receptor. Oxycodone alone or in combination with acetaminophen has been shown to be effective in ameliorating moderate- to moderately severe pain and is widely used for temporary as well as chronic management of pain states. Oxycodone has been in use since its first synthesis in 1917, but was formally approved for use in the United States in 1991. Since then, it has become one of the most commonly prescribed drugs in medical practice. Oxycodone is available in multiple formulations including oral tablets of 5, 7.5, 10 and 20 mg, as well as capsules of 5 mg, suppositories of 10 and 20 mg and oral solution in various concentrations generically. Higher dose oral formulations of 10 to 80 mg are also available generically and under the brand name OxyContin for therapy of persistent, moderate- to moderately severe pain that requires 24 hour opioid therapy. Oxycodone is also available in fixed combinations with other analgesics, including aspirin, ibuprofen, but particularly acetaminophen. These combinations are commonly used and available generically and under the brand names such as Percocet, Tylox and Endocet. The dose of oxycodone is typically 5 to 10 mg and acetaminophen 300 to 600 mg per tablet. Side effects of oxycodone include sedation, respiratory depression, mental clouding, euphoria, agitation, itching, constipation, diarrhea, abdominal bloating, nausea, vomiting, headache and dizziness. Severe adverse events include life-threatening respiratory depression, addiction, abuse, opioid withdrawal, serotonin syndrome (when used with serotonergic agents) and adrenal insufficiency. Oxycodone is a controlled substance and classified as a Schedule II drug, indicating that it has medical usefulness, but also a high potential for physical and psychological dependency and abuse. Unfortunately, oxycodone has become one of the most frequently abused prescription medications and some formulations can be dissolved and injected intravenously. With oxycodone dependence, patients may turn to illegal opiate drug use. Ironically, in some communities, heroin is more available and less expensive than oxycodone by prescription. Tamper deterrent formulations have now become available.

### Hepatotoxicity

Despite wide scale use for many decades, oxycodone has not been convincingly linked to instances of clinically apparent acute liver injury. However, oxycodone and other opioid-acetaminophen combinations have become a common cause of acute liver injury, which is usually the result of excessive use of the medication for the opioid effect, which leads secondarily and unintentionally to an overdose of acetaminophen. In 2014, the FDA warned against the use of opioid combinations in which the dose of acetaminophen is greater than 325 mg per tablet or unit dose. Because of their potential for hepatotoxicity, opioid combinations in which the dose of acetaminophen is greater than 325 mg per tablet or capsule were discontinued.

Oxycodone, like other opiates, is metabolized in the liver by the P450 microsomal oxidizing enzyme system, and levels can be significantly affected by either inhibitors of CYP 3A4 (which increase levels and can lead to toxicity) or inducers of the enzyme (which decrease levels and reduce efficacy).

Likelihood score: E (unlikely cause of drug-induced liver injury).

References on the safety and potential hepatotoxicity of oxycodone are given in the overview section of the Opioids.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Oxycodone – Generic, OxyContin®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Oxycodone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Oxycodone | 76-42-6 | C18-H21-N-O4

## OTHER REFERENCE LINKS

1 Recent References on Oxycodone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Oxycodone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Oxycodone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Oxycodone)